# Piroxicam

## OVERVIEW

### Introduction

Piroxicam is a nonsteroidal antiinflammatory drug (NSAID) that is available by prescription only and is used in therapy of chronic arthritis. Piroxicam can cause mild serum aminotransferase elevations and, in rare instances, leads to clinically apparent acute liver injury that can be severe and even fatal.

### Background

Piroxicam (pir ox' i kam) belongs to the oxicam family, which is a class of enolic acids structurally unrelated to most other NSAIDs. Other oxicam NSAIDs include meloxicam, tenoxicam, and droxicam, the latter two being available in other countries, but not the United States. Piroxicam, like other NSAIDs, acts through inhibition of tissue cyclooxygenases (Cox-1 and -2) leading to a decrease in synthesis of pro-inflammatory prostaglandins, which are potent mediators of pain and inflammation. Piroxicam has analgesic as well as antipyretic and antiinflammatory activities. Piroxicam was approved for use in the United States in 1982, and as a once-a-day NSAID, it was widely used for many years. Recently, however, the number of prescriptions filled yearly in the United States has fallen to less than 200,000, largely because of the availability of other, better tolerated NSAIDs. Current indications include only rheumatoid arthritis and osteoarthritis. Piroxicam is available by prescription only as capsules of 10 and 20 mg in several generic forms as well as under brand names such as Feldene, Novo-Pirocam and Nu-Pirox. The recommended dose is 10 to 20 mg orally once daily. As with other NSAIDs, piroxicam is generally well tolerated, but side effects can include headache, dizziness, somnolence, dyspepsia, abdominal discomfort, diarrhea, peripheral edema and hypersensitivity reactions. Rare but potentially serious adverse events from NSAIDs such as piroxicam include gastrointestinal ulceration, bleeding, and perforation, an increased risk for serious cardiovascular disease including myocardial infarction and stroke, renal dysfunction, exacerbation of asthma, infertility, fetal toxicity, and acute hypersensitivity reactions including anaphylaxis, exfoliative dermatitis, and Stevens Johnson syndrome.

### Hepatotoxicity

Elevated serum aminotransferase levels have been reported in 3% to 18% of patients taking piroxicam, but symptomatic liver disease with jaundice is rare (estimated at 1 to 5 cases per 100,000 prescriptions). The latency to onset of symptoms of clinically apparent liver injury due to piroxicam is variable from a few days to several months, but is generally within the first 1 to 6 weeks of treatment. The pattern of injury is predominantly cholestatic, although cases presenting with mixed or hepatocellular patterns have been reported (Case 1). Eosinophilia, rash and fever can occur, but are not always present and are usually not prominent. Autoantibodies are rarely found. The injury is usually self-limited and recovery occurs within 1 to 2 months. Rare cases of acute liver failure have been reported.

Likelihood score: B (rare but likely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of piroxicam induced liver injury is not known, but may be due to a toxic metabolic intermediate of piroxicam metabolism, which occurs largely in the liver. Cases with allergic manifestations (fever, rash, eosinophilia) may also have a component of hypersensitivity.

### Outcome and Management

Severity of the liver injury from piroxicam ranges from asymptomatic elevations in serum aminotransferase levels to severe hepatitis with acute liver failure. Several instances of chronic vanishing bile duct syndrome have been attributed to other oxicam NSAIDs, but not specifically to piroxicam. In most instances, however, complete recovery is expected after stopping the drug and usually takes one to two months. Cross sensitivity to liver injury among the various NSAIDs has not been well studied or described. Due to the wide availability of alternative medications, rechallenge with piroxicam and other oxicam forms of NSAIDs (meloxicam, droxicam, tenoxicam) should be avoided.

Drug Class: Nonsteroidal Antiinflammatory Drugs, see also Meloxicam

## CASE REPORT

### Case 1. Acute cholestatic hepatitis arising 30 days after starting piroxicam therapy.(1)

A 74 year old woman with chronic arthritis was treated for 30 days with piroxicam and presented 2 days later with pruritus and dark urine followed by jaundice. She had no history of liver disease or exposures to viral hepatitis and did not drink alcohol. She had hypertension and had been treated with atenolol and hydrochlorothiazide chronically. She had no fever or rash, but was jaundiced and had mild hepatic tenderness. Laboratory tests showed a total bilirubin of 6.5 mg/dL and prominent elevations in both ALT and alkaline phosphatase (Table) and eosinophilia. Tests for hepatitis A and B were negative. Ultrasound of the abdomen was normal. A liver biopsy showed intrahepatic cholestasis with minimal portal inflammation suggestive of drug induced liver disease. Her symptoms and jaundice cleared over the month following discontinuation, and on follow up 3 months later, all liver tests were normal.

#### Key Points

Medication: | Piroxicam (20 mg daily)
Pattern: | Mixed→cholestatic (R=3.5→0.8)
Severity: | 2+ (jaundice but never hospitalized)
Latency: | 30 days to onset of symptoms
Recovery: | Complete recovery between 1 and 3 months
Other medications: | Atenolol and hydrochlorothiazide, chronically

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | Piroxicam started for arthritis
30 days | | Piroxicam stopped
32 days | 0 | 694 | 575 | 6.5 | Itching, jaundice
34 days | 6 days | 270 | 736 | 6.2
40 days | 8 days | 358 | 1688 | 3.8 | Liver biopsy
54 days | 23 days | 159 | 1240 | 1.5
60 days | 29 days | 50 | 630 | 0.6
2 months | 1 month | 61 | 291 | 0.6
4 months | 3 months | 36 | 103 | 0.5
Normal Values | | <40 | <280 | <1.2

#### Comment

This patient had the onset of itching after a 30 day course of piroxicam. While the “R” value at the onset of injury (3.5) indicated a “mixed” hepatocellular-cholestatic pattern, the course was clearly cholestatic, with prominence of pruritus, further elevations in alkaline phosphatase (and rapid decreases in ALT yielding R values of <2), and a liver biopsy showing intrahepatic cholestasis with only mild inflammation and hepatocellular necrosis. Immunoallergic features were minimal: there was no rash or fever, but "discrete eosinophilia" was said to be present. Other causes of acute liver injury were effectively ruled out, and she recovered steadily once therapy was stopped. Application of the RUCAM causality system to this case gives a score of 8, which suggests that the likelihood that piroxicam is the cause of the injury is highly probable. As in this case, NSAID related hepatotoxicity may be more common in the elderly and among women.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Piroxicam – Generic, Feldene®

DRUG CLASS

Nonsteroidal Antiinflammatory Drugs

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=PIROXICAM&pagesize=20&page=1)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Piroxicam | 36322-90-4 | C15-H13-N3-O4-S

## CITED REFERENCES

1 Caballeria E, Masso RM, Arago JV, Sanchis A. Piroxicam hepatotoxicity. Am J Gastroenterol 1990; 85: 898-9.2371992

## ANNOTATED BIBLIOGRAPHY

References updated: 05 August 2025

Abbreviations: NSAIDs, nonsteroidal antiinflammatory drugs.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-53. (Expert review of hepatotoxicity published in 1999; piroxicam has been implicated in several instances of liver injury including some with fatal outcomes or requiring liver transplantation).
Lewis JH, Stine JG. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists: pathology and clinical presentation of hepatotoxicity. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. pp. 370-402. (Expert review of liver injury caused by NSAIDs mentions that piroxicam has been reported to cause rare instances of severe hepatic necrosis and cholestatic hepatitis as have other oxicam NSAIDs, two [sudoxicam and isoxicam] having been withdrawn because of hepatotoxicity).
Grossner T, Smyth EM, Fitzgerald GA. Pharmacotherapy of inflammation, fever, pain, and gout. In, Brunton LL, Hilal-Dandan R, Knollman BC. Goodman & Gilman’s The pharmacological basis of therapeutics, 13th ed. New York: McGraw-Hill, 2018. pp. 685-709. (Textbook of pharmacology and therapeutics).
Brogden RN, Heel RC, Speight TM, Avery GS. Piroxicam: a review of its pharmacological properties and therapeutic efficacy. Drugs 1981; 22: 165-87. (Thorough review of pharmacology, structure, indications, efficacy and safety of piroxicam; most common side effects are gastrointestinal; no mention of hepatotoxicity or ALT elevations during treatment). 7021122
Zarski JP, Aubert H, Dentant L, Rachail M. [Hepatitis due to non-steroidal anti-inflammatory agents: a new involved molecule, piroxicam (Feldène) ?] Gastroenterol Clin Biol 1984; 8: 980-1. French. (73 year old man developed weakness 1 month and jaundice 2 months after starting piroxicam [bilirubin 2.8 mg/dL, ALT 2 times ULN, Alk P 3 times ULN], resolving within 2 months of stopping).
Hartmann H, Fischer G, Janning G. Prolonged cholestatic jaundice and leukopenia associated with piroxicam Z Gastroenterol 1984; 22: 343-5. (60 year old woman developed jaundice 2 months after starting piroxicam [bilirubin 8.2 mg/dL, ALT 24 U/L, Alk P 340 U/L with leucopenia, but no eosinophilia], resolving slowly over next 10 weeks). 6485437
Coscojuela C, Charro L, Guallar A, Ferrer-Dufoll MA, Carapeto FJ. [Toxic epidermal necrolysis (Lyell's syndrome) caused by piroxicam, with fatal outcome from disseminated aspergillosis]. Med Cutan Ibero Lat Am 1985; 13: 291-300. Spanish. (71 year old man developed toxic epidermal necrolysis within days of starting piroxicam [AST 220 U/L, GGT 270 U/L without jaundice], resolving within 2 weeks of stopping; nevertheless, the patient died during convalescence of disseminated aspergillosis). 3912630
Lee SM, O'Brien CJ, Williams R, Whitaker S, Gould SR. Subacute hepatic necrosis induced by piroxicam. Br Med J (Clin Res Ed) 1986; 293: 540-1. (66 year old woman developed jaundice 3 days after starting piroxicam [bilirubin rising to 19.0 mg/dL, AST 430 U/L, Alk P 190 U/L, protime 16 seconds], with progression to subacute hepatic failure and death; ANA positive 1:160 and hyperglobulinemia).
Haye OL. Piroxicam and pancreatitis. Ann Intern Med 1986; 104: 895. (42 year old woman developed pancreatitis after taking piroxicam for undefined period [amylase 1048 U/L, liver tests normal], and had rapid recurrence of abdominal pain upon reexposure).
Bismuth H, Samuel D, Gugenheim J, Castaing D, Bernuau J, Rueff B, et al. Emergency liver transplantation for fulminant hepatitis. Ann Intern Med 1987; 107: 337-41. (Description of 17 cases of liver transplantation for fulminant hepatitis including 5 due to drugs – amiodarone, quinidine, piroxicam, clometacine and piroxicam; piroxicam case had bilirubin 26.3 mg/dL, ALT 20 times ULN, and survived with graft). 3304049
Hannequin JR, Doffoel M, Schmutz G. [Hepatitis secondary to current non-steroidal anti-inflammatory agents]. Rev Rhum Mal Osteoartic 1988; 55: 983-8. French. (Report of 83 cases of acute hepatitis due to NSAIDs published in the literature: six cases attributed to piroxicam arising after 1-7 weeks, some with nephritis as well, suspected to be immunoallergic, two cases were fatal). 3070713
Smolinske SC, Hall AH, Vandenberg SA, Spoerke DG, McBride PV. Toxic effects of nonsteroidal anti-inflammatory drugs in overdose. An overview of recent evidence on clinical effects and dose-response relationships. Drug Saf 1990; 5: 252-74. (Review of literature on overdose of NSAIDS: piroxicam overdose typically causes drowsiness, stupor and even coma with mild gastrointestinal upset, but ALT levels may be elevated without jaundice and with rapid return to normal). 2198051
Caballeria E, Masso RM, Arago JV, Sanchis A. Piroxicam hepatotoxicity. Am J Gastroenterol 1990; 85: 898-9. (74 year old woman developed jaundice 30 days after starting piroxicam [bilirubin 6.5 mg/dL, ALT 694 U/L, Alk P 575 U/L, eosinophilia but no rash], resolving within 3 months of stopping: Case 1). 2371992
Planas R, De Leon R, Quer JC, Barranco C, Bruguera M, Gassull MA. Fatal submassive necrosis of the liver associated with piroxicam. Am J Gastroenterol 1990; 85: 468-70. (64 year old woman developed rash 5 days and jaundice 20 days after starting piroxicam [bilirubin 10.9 mg/dL, AST 774 U/L, Alk P 467 U/L], which progressed to liver failure and death 53 days after onset). 2327391
Hepps KS, Maliha GM, Estrada R, Goodgame RW. Severe cholestatic jaundice associated with piroxicam. Gastroenterology 1991; 101: 1737-40. (61 year old man developed jaundice 6 weeks after starting piroxicam which was continued until 12 weeks [bilirubin 15.2 rising to 22 mg/dL, ALT 74 U/L, Alk P 230 U/L], resolving 4 months after stopping). 1955140
Sherman KE, Jones C. Hepatotoxicity associated with piroxicam use. Gastroenterology 1992; 103: 354-5. (61 year old HBsAg-positive woman developed jaundice 12 days after starting piroxicam [bilirubin rising from 1.0 to 20 mg/dL, ALT 1800 U/L, IgM anti-HBc negative, Alk P and HBV DNA not reported], resolving within 3 months of stopping). 1612350
Paterson D, Kerlin P, Walker N, Lynch S, Strong R. Piroxicam induced submassive necrosis of the liver. Gut 1992; 33: 1436-8. (Two case reports; 68 year old woman developed symptomatic hepatitis after 15 months of piroxicam therapy [bilirubin 2.1 mg/dL, ALT 1610 U/L, Alk P 235 U/L, 10% eosinophils], progressing to subacute hepatic failure and death within 3 months of onset; 48 year old man developed jaundice 6 weeks after starting piroxicam [bilirubin 14.2 mg/dL, AST 1860 U/L, Alk P 87, INR 2.4], progressing rapidly to acute liver failure with successful liver transplantation 2 weeks after presentation). 1446877
Jick H, Derby LE, Garcia Rodriguez LA, Jick SS, Dean AD. Liver disease associated with diclofenac, naproxen, and piroxicam. Pharmacotherapy 1992; 12: 207-12. (Analysis of cases of liver injury arising after ~153,000 prescriptions of diclofenac, ~65,000 of piroxicam, ~138,000 of naproxen: 6 cases attributed to naproxen [1 in 20,000 persons], 3 to diclofenac [1 in 50,000], none to piroxicam [less than 1 in 50,000]). 1608854
Morillas Ariño J, Sánchez de la Fuente MF, García-Cano Lizcano J, Jiménez Sánchez F, Rosa Herranz C, Razquin Murillo J, et al. [Hepatotoxicity induced by Droxicam: presentation of 4 cases]. Rev Esp Enferm Dig 1993; 83: 197-201. Spanish. (4 cases of liver injury arising on droxicam, a prodrug of piroxicam not available in the US, with onset after 10-32 days of therapy [bilirubin 2.0, 23.2, 2.1, and 14.3 mg/dL; ALT 406-708 U/L; Alk P 991-2082 U/L], resolving within 2-10 months of stopping, 2 had mild eosinophilia; one had long term Alk P elevations). 8489815
Jobard JM, Ory JP, Cleau D, Debieuvre D. [Symptomatic hepatic disorders after ingestion of tenoxicam] Gastroenterol Clin Biol 1993; 17: 614-5. French. (32 year old man developed severe fatigue 7 days after starting tenoxicam [no jaundice, ALT 592 U/L, Alk P 643 U/L], resolving rapidly with stopping, all tests being normal 3 months later). 8253331
García Rodríguez LA, Williams R, Derby LE, Dean AD, Jick H. Acute liver injury associated with nonsteroidal anti-inflammatory drugs and the role of risk factors. Arch Intern Med 1994; 154: 311-6. (Retrospective cohort study of cases of acute liver injury in England after exposure to NSAIDs; 23 cases identified , none fatal, including 5 attributed to ibuprofen, 4 diclofenac, 4 naproxen, 2 mefenamic acid, 3 ketoprofen, 2 piroxicam, 2 fenbuten and 3 sulindac). 8297198
Sungur C, Ates B, Akbas O. Acute hepatitis caused by tenoxicam. Ann Pharmacother 1994; 28: 1309. (77 year old woman developed abdominal pain and jaundice 3 days after starting tenoxicam [an oxicam NSAID not available in the US] for back pain [bilirubin 3.0 mg/dL, ALT 406 U/L, Alk P 292 U/L], resolving within 2 weeks of stopping).
Pascual AF, Jimenez Martos F, Rodriguez Moreno C. [Cholestatic hepatitis associated with tenoxicam] Aten Primaria 1995; 15: 329. Spanish. (84 year old woman developed abdominal pain and itching 6 months after starting tenoxicam [ALT 141 U/L, Alk P 310 U/L, bilirubin not mentioned], resolving within 30 days of stopping).
Walker AM. Quantitative studies of the risk of serious hepatic injury in persons using nonsteroidal antiinflammatory drugs. Arthritis Rheum 1997; 40: 201-8. (Review of population based studies of NSAID use and hepatic injury; estimated frequency of piroxicam hepatotoxicity varied from 9 to 14 per 100,000 person-years of use). 9041931
Katsinelos P, Katsos I, Patsiaoura K, Xiarchos P, Goulis I, Eugenidis N. Tenoxicam-associated hepatic injury: a case report and review. Eur J Gastroenterol Hepatol 1997; 9: 403-6. (51 year old woman developed jaundice within 4 days of starting tenoxicam [bilirubin 3.0 mg/dL, ALT 157 U/L, Alk P 365 U/L], resolving within 7 weeks of stopping). 9160206
Poniachik J, Guerrero J, Calderón P, Smok G, Morales A, Muñoz G, et al. [Cholestatic hepatitis associated with piroxicam use. Case report]. Rev Med Chil 1998; 126: 548-52. Spanish. (22 year old woman developed jaundice several months after starting piroxicam [bilirubin 7.8 mg/dL, ALT 387 U/L, Alk P 784 U/L], resolving within 8 weeks of stopping). 9731437
Gutiérrez A, Enriquez R, Amorós F, Sillero C, Reyes A. [Acute hepatic and renal failure due to piroxicam use] Rev Esp Enferm Dig. 2002; 94: 169-70. Spanish. (33 year old man developed fever and jaundice 12 months after starting intermittent piroxicam [bilirubin 3.2 mg/dL, ALT 4828 U/L, Alk P normal], also developing renal insufficiency [creatinine 8.2 mg/dL]; recovery within 2 weeks). 12185885
Trak-Smayra V, Cazals-Hatem D, Asselah T, Duchatelle V, Degott C. Prolonged cholestasis and ductopenia associated with tenoxicam. J Hepatol 2003; 39: 125-8. (36 year old man developed fever and jaundice 7 days after starting tenoxicam [an oxicam NSAID available in Europe], with bilirubin 30.9 mg/dL, ALT 1159 U/L, Alk P 2710 U/L and prolonged jaundice and biopsy showing cholangitis and intrahepatic cholestasis, very slow recovery marked by persistence of Alk P >1000 U/L, and repeat liver biopsies over 3 years showing progressive ductopenia). 12821054
Lacroix I, Lapeyre-Mestre M, Bagheri H, Pathak A, Montastruc JL; Club de Reflexion des cabinets de Groupe de Gastro-Enterologie(CREGG); General Practitioner Networks. Nonsteroidal anti-inflammatory drug-induced liver injury: a case-control study in primary care. Fundam Clin Pharmacol 2004; 18: 201-6. (Case controlled study of patients presenting with suspected drug induced liver injury in a general practice context in Southern France found 88 cases which were matched with 178 controls; 22 cases vs 16 controls were exposed to NSAIDs; 5 diclofenac, 4 ibuprofen, 4 ketoprofen, 2 niflumic acid, 1 flurbiprofen and 1 meloxicam, the rest to salicylates which was just as commonly used in controls; piroxicam not mentioned). 15066135
de Abajo FJ, Montero D, Madurga M, García Rodríguez LA. Acute and clinically relevant drug-induced liver injury: a population based case-control study. Br J Clin Pharmacol 2004; 58: 71-80. (Population based study of 1.6 million persons in UK found 128 suspected cases of drug induced liver disease, calculated odds ratios for liver injury to be 4.1 for diclofenac, but 0.4 for all other NSAIDs [2 cases only, both due to naproxen]). 15206996
Andrade RJ, Lucena MI, Fernández MC, et al.; Spanish Group for the Study of Drug-Induced Liver Disease. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Reports to a Spanish network found 570 cases of drug induced liver disease with ibuprofen listed as 4th major cause; 18 cases in all: half mixed, half hepatocellular; eosinophilia in 2; acute liver failure in 2, one death and one liver transplant; piroxicam not mentioned). 16083708
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Summary of 25 years of adverse drug reaction reporting in Sweden identified 103 cases of drug induced acute liver failure; diclofenac and naproxen mentioned in top 20 causes; ibuprofen listed as associated with one case, but piroxicam not mentioned). 16165719
Lapeyre-Mestre M, de Castro AM, Bareille MP, Del Pozo JG, Requejo AA, Arias LM, et al. Non-steroidal anti-inflammatory drug-related hepatic damage in France and Spain: analysis from national spontaneous reporting systems. Fundam Clin Pharmacol 2006; 20: 391-5. (Analysis of reports of liver injury from NSAIDs from France and Spain from 1982-2001; relative risk definitely raised for droxicam, sulindac, nimesulide, and clometacin; minimally raised for naproxen, diclofenac, piroxicam and tenoxicam; 33 hepatic adverse events due to piroxicam reported from Spain and 378 from France). 16867024
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, NSAIDs were implicated as a sole agent in 8 cases [4 diclofenac, 2 celecoxib, 1 meloxicam, 1 oxaprozin] and as one of several agents in 3 cases [1 diclofenac, 1 celecoxib, 1 ibuprofen], but none attributed to piroxicam). 18955056
Bessone F. Non-steroidal anti-inflammatory drugs: What is the actual risk of liver damage? World J Gastroenterol 2010; 16: 5651-61. (Review of estimated frequency of drug induced liver injury due to NSAIDs from large published epidemiological studies; mentions personal experience with two cases of piroxicam induced liver injury, one a 42 year old woman who developed acute liver failure 28 days after starting drug who eventually recovered, and a 42 year old man with severe and prolonged cholestasis which arose after 58 days of piroxicam use). 21128314
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which 7 were due to NSAIDs, including 4 attributed to bromfenac, 2 to diclofenac and 1 to etodolac, but none to piroxicam). 20949552
Lapeyre-Mestre M, Grolleau S, Montastruc JL; Adsociation Française des Centres Régionaux de Pharmacovigilance (CRPV). Adverse drug reactions associated with the use of NSAIDs: a case/noncase analysis of spontaneous reports from the French pharmacovigilance database 2002-2006. Fundam Clin Pharmacol 2013; 27: 223-30. (Analysis of spontaneous reporting of 42,389 adverse events to the French Pharmacovigilance database for 8 NSAIDs between 2002 and 2006; hepatic events per million daily doses was highest for nimesulide [0.15], compared to diclofenac [0.09], ketoprofen [0.09], naproxen [0.04], meloxicam [0.03], tenoxicam [0.03] and piroxicam [0.06]). 21929527
Suzuki A, Andrade RJ, Björnsson E, Lucena MI, Lee WM, Yuen NA, Hunt CM, et al. Drugs associated with hepatotoxicity and their reporting frequency of liver adverse events in VigiBase: unified list based on international collaborative work. Drug Saf 2010; 33: 503-22. (The combination of several large data sources identified 385 different drugs to be linked to liver injury and 107 to acute liver failure, the most commonly implicated NSAIDs being diclofenac, ibuprofen, naproxen, nimesulide, piroxicam, and sulindac). 20486732
Zhou Y, Yang L, Liao Z, He X, Zhou Y, Guo H. Epidemiology of drug-induced liver injury in China: a systematic analysis of the Chinese literature including 21 789 patients. Eur J Gastroenterol Hepatol 2013; 25: 825-9. (Search of 3 electronic databases of the Chinese medical literature from 1994-2011 identified 279 reports on a total of 24,111 patients with drug induced liver injury, the most commonly implicated being antituberculosis agents [31%], HDS products [19%], antibiotics [10%] and NSAIDs [7.6%], and the most frequent individual NSAIDs being acetaminophen, ibuprofen, indomethacin, aspirin and phenylbutazone). 23510965
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (Prospective analysis of all cases of drug induced liver injury in Iceland between 2010-11 identified 97 cases [19 per 100,000 inhabitants], 6 of which were attributed to diclofenac; no other NSAID mentioned). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common class of implicated agents being NSAIDs [n=62, 32%], and specific agents were nimesulide [n=53], piroxicam [5], diclofenac [2], gold salts [1], and naproxen [1]). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 28 were attributed to NSAIDs [Schmeltzer 2016]). 25754159
Schmeltzer PA, Kosinski AS, Kleiner DE, Hoofnagle JH, Stolz A, Fontana RJ, Russo MW; Drug-Induced Liver Injury Network (DILIN). Liver injury from nonsteroidal anti-inflammatory drugs in the United States. Liver Int 2016; 36: 603-9. (Among 1221 cases of drug induced liver injury enrolled in a prospective, US database between 2004 and 2014, 30 cases [2.5%] were attributed to NSAIDs, most commonly diclofenac [n=16], but also celecoxib [3], meloxicam [3], etodolac [2], ibuprofen [2], oxaprozin [2], valdecoxib [1] and sulindac [1]; none were due to piroxicam). 26601797
Donati M, Conforti A, Lenti MC, Capuano A, Bortolami O, Motola D, Moretti U, et al.; DILI-IT Study Group. Risk of acute and serious liver injury associated to nimesulide and other NSAIDs: data from drug-induced liver injury case-control study in Italy. Br J Clin Pharmacol 2016; 82: 238-48. (Among 179 cases of acute liver injury and 1770 controls admitted to 9 Italian hospitals between 2010 and 2014, NSAIDs used more frequently in cases compared to controls included nimesulide [17% vs 10%: odds ratio 1.88] and ibuprofen [14% vs 10%: odds ratio 1.59] and risk was higher in those taking higher doses). 26991794
Zoubek ME, González-Jimenez A, Medina-Cáliz I, Robles-Díaz M, Hernandez N, Romero-Gómez M, Bessone F, et al. High Prevalence of ibuprofen drug-induced Liver injury in Spanish and Latin-American registries. Clin Gastroenterol Hepatol 2018; 16: 292-4. (Analysis of a Spanish and Latin-American registries identified 73 cases of NSAID induced liver injury, the most common agents being nimesulide [38%], diclofenac [34%] and ibuprofen [17%]; other agents not mentioned). 28782674
Tujios SR, Lee WM. Acute liver failure induced by idiosyncratic reaction to drugs: challenges in diagnosis and therapy. Liver Int 2018; 38: 6-14. (Review of acute liver failure and the contribution of drug induced liver injury, of which 5% were due to NSAIDs, most commonly diclofenac and etodolac). 28771932
Meunier L, Larrey D. Recent advances in hepatotoxicity of non-steroidal anti-inflammatory drugs. Ann Hepatol 2018; 17: 187-91. (Review of the hepatotoxicity of NSAIDS mentions the most commonly implicated are diclofenac, nimesulide, sulindac, ibuprofen, piroxicam, naproxen, and aspirin). 29469052
Nonopioid drugs for pain. Med Lett Drugs Ther. 2022;64(1645):33-40. (Concise review of the nonopioid drugs for pain mentions that NSAIDs are considered to be more effective than acetaminophen for mild to moderate pain and that they can cause small increases in serum aminotransferase levels but that serious hepatotoxicity is rare, occurring most frequently with diclofenac, while cholestatic hepatitis has been reported with use of celecoxib). 35231019
Bonkovsky HL, Ghabril M, Nicoletti P, Dellinger A, Fontana RJ, Barnhart H, Gu J, et al; US DILIN Investigators. Drug-induced liver injury (DILI) ascribed to non-steroidal anti-inflammatory drugs (NSAIDs) in the USA-update with genetic correlations. Liver Int. 2024;44:1409-1421. (Among 55 cases of drug induced liver injury attributed to NSAIDs enrolled in a U.S. database between 2004 and 2022, 29 were attributed to diclofenac, 7 to celecoxib, 5 to ibuprofen, 4 to etodolac and meloxicam, 2 to oxaprozin, and 1 to naproxen and sulindac, but none to piroxicam). 38451034
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be attributed to prescribed medications, at rates for NSAIDs of 1:7,700 for sulindac, 1:8,300 for indomethacin, 1:9,100 for naproxen, 1:11,000 for ibuprofen, 1:12,500 for diclofenac, and 1:14,300 for celecoxib; piroxicam was not mentioned). 38913369
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver injury caused by prescription drugs. Drug Saf. 2025;48:151-160. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study, identified 23 cases due to diclofenac for an estimated incidence of 1 per 4,800 new persons treated each year, while other NSAIDs had lower numbers and estimated rates, including celecoxib [4, 1:25,000] and meloxicam [n=3, 1:87,000], there were no cases due to piroxicam and incidence could not be estimated). 39317916
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102. (Among 458 cases of idiosyncratic drug-induced liver injury enrolled in a prospective Latin American database over a 10 year period, 49 were attributed to NSAIDs, including 19 [4.1%] to diclofenac, 14 [3.0%] to nimesulide and 11 [2.4%] to ibuprofen, and 1 case each to celecoxib, ketoprofen, ketorolac, meloxicam, and piroxicam [personal communication]). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Piroxicam: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(piroxicam/AE+NOT+clavulanic+acid)+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Piroxicam: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=piroxicam)